# Antiemetic Agents

## OVERVIEW

Antiemetics are used for the symptomatic management of nausea and vomiting that can be caused by a variety of medical conditions and situations, including acute gastroenteritis, pregnancy, surgery, anesthesia, opioids and chemotherapy. Antiemetics are rare causes of liver injury, partially because they are used in low doses and for a short time only.

Antiemetics can be categorized based upon their mechanism of action, their receptor activity or their chemical structure. Antihistamines have mild antiemetic activity and are commonly used for motion sickness and the transient nausea that might accompany a viral illness or gastrointestinal infection or disorder. Antihistamines that are commonly used for nausea include cyclizine, chlorcyclizine, diphenhydramine, dimenhydrinate, doxylamine, meclizine, hydroxyzine and promethazine. The anticholinergics also have antiemetic activity, although their other side effects often outweigh any relief they might provide for nausea. Nevertheless, some anticholinergics are used alone or in combination with other agents for mild nausea and vomiting, including scopolamine and hyoscyamine. Phenothiazines, which are typically used as antipsychotic medications, also have antiemetic effects and several minor phenothiazines are used to treat transient nausea and vomiting associated with viral infections, surgery or gastrointestinal illnesses.

More potent antiemetics used in restricted situations include cannabinoid agonists, serotonin receptor antagonists and antagonists of the neurokinin 1 (NK-1) receptor for substance P. Cannabinoid agonists have potent activity against nausea and can also stimulate appetite. The cannabinoids are generally reserved for patients with recurrent nausea, particularly if accompanied by cachexia as might occur with cancer chemotherapy. Cannabinoids in current use for nausea and cachexia include tetrahydrocannabinol (THC), nabilone and dronabinol as well as cannabis itself, often referred to as medical marijuana. The serotonin type 3 (5-HT3) receptor antagonists have potent activity both in the central nervous system and the gastrointestinal tract and are used to treat postoperative and chemotherapy induced nausea and vomiting. They typically can also cause diarrhea or constipation, dizziness and fatigue and are usually give for a limited time in persons with severe temporary nausea and vomiting. Antagonists of the neurokinin 1 receptor for substance P are very potent inhibitors of nausea and vomiting, and particularly the delayed (>24 hours) nausea and vomiting after cyclic cancer chemotherapy. These agents include aprepitant, fosaprepitant and rolapitant and are generally given for a short time only during cyclic, highly emetigenic cancer chemotherapy.

Finally, there are miscellaneous antiemetics that may have other major activities, the effect on nausea and vomiting being a secondary effect. These agents include trimethobenzamide, metoclopramide, tegaserod and octreotide.

Antiemetics that are discussed in LiverTox are listed below:

- Anticholinergic Agents
  - Hyoscyamine, Methscopolamine, Scopolamine
- Antihistamines
  - Cyclizine, Dimenhydrinate, Hydroxyzine, Meclizine, Promethazine
- Cannabinoid Receptor Agonists
  - Dronabinol, Nabilone, Tetrahydrocannabinol
- Phenothiazines [See Antipsychotic Agents]
  - Chlorpromazine, Prochlorperazine
- Serotonin 5-HT3 Receptor Antagonists
  - Alosetron, Dolasetron, Granisetron, Ondansetron, Palonosetron
- Substance P/Neurokinin 1 Receptor Antagonists
  - Aprepitant, Fosaprepitant, Fosnetupitant, Rolapitant
- Miscellaneous
  - Amisulpride, Dexamethasone, Metoclopramide, Trimethobenzamide

References to the safety and potential hepatotoxicity of the various antiemetics are given with the specific drug records.

Drug Class: Gastrointestinal Agents